# Chlorambucil

## OVERVIEW

### Introduction

Chlorambucil is an orally administered alkylating agent which is currently used in the therapy of chronic lymphocytic leukemia, Hodgkin and non-Hodgkin lymphomas, and rarely in severe autoimmune conditions including rheumatoid arthritis, uveitis and nephrotic syndrome. Chlorambucil therapy has been associated with low rates of serum enzyme elevations during therapy and to rare instances of acute, clinically apparent injury.

### Background

Chlorambucil (klor am' bue sil) is an orally available, alkylating agent similar to mechlorethamine, cyclophosphamide and melphalan (nitrogen mustard-like). The alkylating agents act by causing modification and cross linking of DNA, thus inhibiting DNA, RNA and protein synthesis and causing cell death in rapidly dividing cells. Alkylating agents also have immunosuppressive activity, and chlorambucil has also been used in the therapy of autoimmune diseases and allograft rejection. Chlorambucil was approved for use in the United States in 1957. Current major indications include Hodgkin and non-Hodgkin lymphomas, chronic lymphocytic leukemia and lymphosarcoma. Chlorambucil has also been used for macroglobulinemia, polycythemia vera, rheumatoid arthritis, autoimmune uveitis and minimal change nephrotic syndrome, but its link to development of leukemia and secondary cancers has led to recommendations that its use be restricted to malignant conditions. Chlorambucil is available as Leukeran in tablets of 2 mg, and the usual dose ranges from 2 to 10 mg daily, often being given long term. Chlorambucil is generally well tolerated, and flexible dosing allows for dose adjustment to minimize side effects. Chlorambucil shares common side effects with other alkylating agents such as nausea, vomiting, diarrhea, alopecia, oral ulcers, bone marrow suppression, hypersensitivity reactions and rash. Long term therapy may be associated with an increased rate of acute myelocytic leukemia, interstitial pneumonitis and pulmonary fibrosis. Acute hypersensitivity reactions are rare but can include drug fever, angioedema, erythema multiforme, and Stevens Johnson syndrome.

### Hepatotoxicity

Chlorambucil therapy is associated with a low rate of serum enzyme elevations, but these are generally mild and self limited, not requiring dose adjustment. Rare instances of clinically apparent acute liver injury attributed to chlorambucil have been reported. The onset of symptoms was within 2 to 6 weeks of starting chlorambucil and the typical enzyme pattern was cholestatic. Some cases have had features of hypersensitivity (rash, fever), and liver injury has recurred upon rechallenge. This form of liver injury is rare and resembles the idiosyncratic acute liver injury due to cyclophosphamide. Chlorambucil has not been linked specifically to sinusoidal obstruction syndrome, but it is not used in high doses in neoplastic disease or in conditioning regimens for hematopoietic cell transplantation, situations in which alkylating agents are commonly associated with this complication. Chlorambucil therapy has also been linked to hypersensitivity reactions and severe cutaneous adverse events such as Stevens Johnson syndrome and toxic epidermal necrolysis, both of which can be accompanied by serum enzyme elevations and hepatitis.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The idiosyncratic cholestatic liver injury associated with chlorambucil use is probably related to a hypersensitivity reaction to a hepatic metabolite of the drug, which is extensively metabolized by the liver.

### Outcome and Management

Liver injury is rare after chlorambucil therapy. The severity of injury in reported cases has been mild-to-moderate and self limited in course. There have been no instances of acute liver failure, chronic hepatitis or vanishing bile duct syndrome definitively linked to chlorambucil therapy. In situations of acute liver injury after chlorambucil use, rechallenge should be avoided and there may be some degree of cross sensitivity to allergic reactions with other nitrogen mustard-like alkylating agents such as cyclophosphamide and melphalan.

Drug Class: Antineoplastic Agents, Alkylating Agents

## CASE REPORT

### Case 1. Cholestatic hepatitis attributed to chlorambucil.

[Modified from: Pichon N, Debette-Gratien M, Cessot F, Paraf F, Labrousse F, Sautereau D, Pillegand B. [Acute cholestatic hepatitis caused by chlorambucil]. Gastroenterol Clin Biol 2001; 25: 202-3. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/11319447)]

A 77 year old woman with non-Hodgkin lymphoma developed pruritus and jaundice 6 weeks after starting oral chlorambucil (4 mg daily). She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. Her other medications included sertraline which she had taken for 6 months. On examination, she had splenomegaly which was unchanged from before and new findings of jaundice and excoriations over the forearms. Laboratory testing showed a total serum bilirubin of 13.3 mg/dL (direct 11.8 mg/dL), accompanied by elevations in serum aminotransferase and alkaline phosphatase levels (Table). There was no eosinophilia and the prothrombin time was normal. Tests for hepatitis A, B and C were negative as were autoantibodies. Ultrasound and computerized tomography of the abdomen showed no evidence of biliary obstruction, which was further confirmed by magnetic resonance cholangio-pancreatography. A liver biopsy showed an intrahepatic cholestasis with prominence of eosinophils suggestive of drug induced liver injury. There was also mild congestion of sinusoids and changes of peliosis. There was no bile duct injury or loss. Both chlorambucil and sertraline were stopped and her symptoms and liver test abnormalities gradually improved. Sertaline was restarted and all laboratory results were normal 2 months later.

#### Key Points

Medication: | Chlorambucil
Pattern: | Cholestatic (R=0.4)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 6 weeks
Recovery: | 2 months
Other medications: | Sertraline

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin (mg/dL) | Other
0 | | <40 | <115 | <1.0
6 weeks | 0 | 80 | 520 | 13.3 | Medications stopped
7 weeks | 1 week | 60 | 230 | 33.1
8 weeks | 2 weeks | <40 | 180 | 9.9
9 weeks | 3 weeks | <40 | <115 | 1.7 | Sertaline restarted
4 months | 2 months | <40 | <115 | 0.9
Normal Values | | <40 | <115 | <1.2

* Modified from Table 1.

#### Comment

A typical case of cholestatic hepatitis in which chlorambucil was the likely cause. Sertraline has also been associated with drug induced liver injury, but was unlikely the cause in this instance as shown by the negative rechallenge. The appearance of pruritus at the onset of illness and prolonged jaundice are typical of drug induced cholestatic hepatitis.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Chlorambucil – Leukeran®

DRUG CLASS

Antineoplastic Agents, Alkylating

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Chlorambucil)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Chlorambucil | 305-03-3 | C14-H19-Cl2-N-O2 | Chlorambucil Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 05 October 2017

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; mentions that chlorambucil has been linked to several reports of liver injury, which has usually been hepatocellular and occasionally severe).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 549-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; chlorambucil is not specifically discussed).
Chabner BA, Bertino J, Clearly J, Ortiz T, Lane A, Supko JG, Ryan DP. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1677-730. (Textbook of pharmacology and therapeutics).
Koler RD, Forsgren AL. Hepatotoxicity due to chlorambucil; report of a case. JAMA 1958; 167: 316-7. (36 year old man with chronic lymphocytic leukemia developed rash 2 weeks after starting chlorambucil, followed by nausea and jaundice [bilirubin 6.2], resolving within 6 weeks of stopping; rash and hepatomegaly recurred 3 days after restarting chlorambucil). 13538708
Amromin GD, Deliman RM, Shanbrom E. Liver damage after chemotherapy for leukemia and lymphoma. Gastroenterology 1962; 42: 401-10. (Among 181 patients receiving chemotherapy for cancer, 22 [16%] developed jaundice, 10 being attributed to chemotherapy, 6 possibly due to chlorambucil with onset after 18-75 days with degenerative and cholestatic changes on biopsy). 13861044
Morgano G, Patrone E, Muratore A. [Atypical aspects of leukoses. Venous thrombosis; jaundice]. Minerva Med 1969; 60: 1106-11. Italian. (69 year old man with chronic lymphocytic leukemia developed jaundice within a month of starting chlorambucil [bilirubin not given, ALT 340 U/L, Alk P 2 times ULN], resolving after stopping). 5252723
Jick H, Walker AM, Porter J. Drug-induced liver disease. J Clin Pharmacol 1981; 21: 359-64. (Among 144 medical inpatients receiving chlorambucil, one [57 year old woman with hemolytic anemia] developed drug induced liver injury after 13 days of use; recovered after discontinuation; no specific details given). 7276230
Renambot J, Aubry P, Menard M, Dano P, Brunetti G. [Hepatocellular carcinoma in an African after 10 years of treatment of Waldenstrom's disease with chlorambucil]. Nouv Presse Med 1982; 11: 2418. French. (47 year old Senegalese man with Waldenstrom macroglobulinemia treated with chlorambucil for 10 years developed hepatocellular carcinoma, but without cirrhosis and with negative tests for HBsAg [immunodiffusion]). 6287413
Rollins BJ. Hepatic veno-occlusive disease. Am J Med 1986; 8: 297-306. (Review of the diagnosis, clinical course, histology and pathogenesis of veno-occlusive disease, now referred to as sinusoidal obstruction syndrome [SOS]). 3526887
Jones RJ, Lee KS, Beschorner WE, Vogel VG, Grochow LB, Braine HG, Vogelsang GB, et al. Veno-occlusive disease of the liver following bone marrow transplantation. Transplantation 1987; 4: 778-83. (Among 235 patients undergoing hematopoietic cell transplantation between 1982 and 1985, sinusoidal obstruction syndrome [SOS] developed in 52 [22%] of whom half died, making SOS the third most common cause of death in this population). 3321587
Barone C, Cassano A, Astone A. Toxic epidermal necrolysis during chlorambucil therapy in chronic lymphocytic leukaemia. Eur J Cancer 1990; 26: 1262. (57 year old woman with CLL developed toxic epidermal necrosis after 18 days of chlorambucil therapy, and recurrence of rash and bullae within a few hours of restarting it; no mention of jaundice or liver test results). 2150004
Aydogdu I, Ozcan C, Harputluoglu M, Karincaoglu Y, Turhan O, Ozcanu A. Severe adverse skin reaction to chlorambucil in a patient with chronic lymphocytic leukemia. Anticancer Drugs 1997; 8: 468-9. (60 year old man with CLL developed toxic epidermal necrolysis 20 days after starting chlorambucil, which resolved within 3 weeks of stopping; no mention of liver test results). 9215610
Pichon N, Debette-Gratien M, Cessot F, Paraf F, Labrousse F, Sautereau D, Pillegand B. [Acute cholestatic hepatitis caused by chlorambucil]. Gastroenterol Clin Biol 2001; 25: 202-3. (77 year old woman with non-Hodgkin lymphoma developed pruritus and jaundice 6 weeks after starting chlorambucil [4 mg/day], [bilirubin 29.8 mg/dL, ALT 2 times ULN, Alk P 4.5 times ULN, no eosinophilia], resolving within 3 months of stopping: Case 1). 11319447
Bearman SI. The syndrome of hepatic veno-occlusive disease after marrow transplantation. Blood 1995; 85: 3005-20. (Review of hepatic veno-occlusive disease after bone marrow transplantation; usually presents with painful hepatomegaly, weight gain [fluid and ascites] and jaundice within 3 weeks of myeloablation with occlusion of central veins and sinusoids and extensive zone 3 [centrolobular] injury). 7756636
Idasiak-Piechocka I, Oko A, Łochyńska-Bielecka K, Skrobańska B. Efficacy and safety of low-dose chlorambucil in nephrotic patients with idiopathic membranous nephropathy. Kidney Blood Press Res 2009; 32: 263-7. (Among 32 patients with membranous nephropathy treated with chlorambucil and corticosteroids, none had serious adverse events or hepatotoxicity). 19776643
Knauf WU, Lissichkov T, Aldaoud A, Liberati A, Loscertales J, Herbrecht R, Juliusson G, et al. Phase III randomized study of bendamustine compared with chlorambucil in previously untreated patients with chronic lymphocytic leukemia. J Clin Oncol 2009; 27: 4378-84. (Among 312 patients with chronic lymphocytic leukemia treated with chlorambucil or bendamustine for up to 4 years, clinical responses were more common with bendamustine [68% vs 31%], while side effects were similar and there was no mention of ALT elevations or hepatotoxicity). 19652068
Rosen AC, Balagula Y, Raisch DW, Garg V, Nardone B, Larsen N, Sorrell J, et al. Life-threatening dermatologic adverse events in oncology. Anticancer Drugs 2014; 25: 225-34. (In a systematic review of reports of Stevens Johnson Syndrome and toxic epidermal necrolysis due to antineoplastic agents from the literature and the MedWatch system, chlorambucil is listed as one of the more common implicated agents in serious cutaneous reactions, although most patients were taking other potentially causative medications). 24108082
Hillmen P, Gribben JG, Follows GA, Milligan D, Sayala HA, Moreton P, Oscier DG, et al. Rituximab plus chlorambucil as first-line treatment for chronic lymphocytic leukemia: Final analysis of an open-label phase II study. J Clin Oncol 2014; 32: 1236-41. (Among 100 patients with CLL treated with rituximab and chlorambucil in 6 28-day cycles, the overall response rate was 84% and adverse events were mostly hematologic; there were no serious adverse hepatic events and no mention of ALT elevations). 24638012
Hillmen P, Robak T, Janssens A, Babu KG, Kloczko J, Grosicki S, Doubek M, et al; COMPLEMENT 1 Study Investigators. Chlorambucil plus ofatumumab versus chlorambucil alone in previously untreated patients with chronic lymphocytic leukaemia (COMPLEMENT 1): a randomised, multicentre, open-label phase 3 trial. Lancet 2015; 385 (9980): 1873-83. (Among 447 patients with CLL treated with chlorambucil with or without ofatumumab [anti-CD20 monoclonal antibody], progression free survival was greater with ofatumumab [22 vs 13 months] as were overall adverse event rates, but there were no liver-related serious adverse events or deaths). 25882396
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 cases [5%] were attributed to antineoplastic agents including several to alkylating agents, but none to chlorambucil). 25754159
Lepretre S, Dartigeas C, Feugier P, Marty M, Salles G. Systematic review of the recent evidence for the efficacy and safety of chlorambucil in the treatment of B-cell malignancies. Leuk Lymphoma 2016; 57: 852-65. (In a systematic review of 9 controlled trials of chlorambucil for B-cell malignancies, its adverse event rate was considered low, the most common events being nausea, neutropenia, and lymphopenia; no mention of ALT elevations or hepatotoxicity). 26308278

## OTHER REFERENCE LINKS

1. Recent References on Chlorambucil: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Chlorambucil/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Chlorambucil: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Chlorambucil)